# Fenugreek

## OVERVIEW

### Introduction

Fenugreek is an herb prepared from the dried seeds of Trigonella foenum-graecum which is used for its antioxidant and glucose- and cholesterol-lowering effects in the treatment of fever, vomiting, poor appetite, diabetes and hypercholesterolemia. Fenugreek has not been implicated in causing liver injury.

### Background

Fenugreek is an herb extract prepared from the dried seeds of Trigonella foenum-graecum (sicklefruit fenugreek), a plant belonging to the pea family (Fabaceae). It is native to India and northern Africa and is one of the oldest medicinal plants is continuous use. In Chinese medicine, fenugreek seeds were used as a tonic; in Indian medicine, as a stimulant to lactation; and, in many folk medicines as an aid to digestion and treatment of baldness. Investigation of its activity in animal models suggested that fenugreek extracts have antioxidant, antihyperlipidemic and hypoglycemic activities. Constituents of fenugreek extracts include dietary fibers, mucilages, steroid saponins, flavonoids, trigonelline, and volatile oils. The lipid- and glucose-lowering effects of fenugreek have been attributed to saponins. The benefits of fenugreek therapy in hypercholesterolemia and diabetes in humans have not been proven in rigorously designed prospective clinical trials. Nevertheless, fenugreek is widely used, often in combination with conventional therapies. The usual doses used to aid in the management of diabetes and hypercholesterolemia are variable, ranging from 2 to 100 grams daily taken in 2 or 3 divided doses either as capsules or as powder to prepare teas. Fenugreek preparations contain high levels of fiber, which may represent 50% of its constituents. Fenugreek is also used topically and in foods as a flavoring agent. Side effects of oral fenugreek are minor and include gastrointestinal upset, nausea, diarrhea, bloating, flatulence, and allergic reactions with facial edema, wheezing, dizziness and shock.

### Hepatotoxicity

Despite being widely used, fenugreek has not been implicated in cases of clinically apparent liver injury and, in prospective studies, has had no effect on serum enzyme levels. In vitro studies have demonstrated hepatoprotective activity of fenugreek extracts in several animal models. Because of the high fiber content, estrogenic and coumadin-like effects of fenugreek, it has a potential to cause herb-drug interactions particularly if taken in high doses with antiplatelet drugs and warfarin.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Alholva, Bird’s Foot, Bockshornklee, Fenogreco, Greek Clover, Greek Hay, Hu Lu Ba, Methi, Trigonella, Woo Lu Bar.

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fenugreek – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/fenugreek)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fenugreek | 0977155295 | Herbal mixture | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 29 January 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; fenugreek is not discussed).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbal and dietary supplements [HDS] ; fenugreek is not discussed).
Fenugreek. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 319-20. (Compilation of short monographs on herbal medications and dietary supplements).
Sushma N, Devasena T. Aqueous extract of Trigonella foenum graecum(fenugreek) prevents cypermethrin-induced hepatotoxicity and nephrotoxicity. Hum Exp Toxicol 2010; 29: 311-9. (Fenugreek decreased the hepatic and renal toxicity of the pesticide cypermethrin in rats). 20147568
Thirunavukkarasu V, Anuradha CV, Viswanathan P. Protective effect of fenugreek (Trigonella foenum graecum) seeds in experimental ethanol toxicity. Phytother Res 2003; 17: 737-43. (Fenugreek extracts decreased enzyme elevations and markers of lipid peroxidation in a rat model of alcohol hepatotoxicity). 12916070
Ulbricht C, Basch E, Burke D, Cheung L, Ernst E, Giese N, Foppa I, et al. Fenugreek (Trigonella foenum-graecum L. Leguminosae): an evidence-based systematic review by the natural standard research collaboration. J Herb Pharmacother 2007; 7: 143-77. (Extensive review of laboratory and clinical data of medicinal effects of fenugreek; “Literature review reveals no reports of clinically significant harmful adverse effects,” no mention of effect on ALT levels or hepatotoxicity). 18928139
Thompson Coon JS, Ernst E. Herbs for serum cholesterol reduction: a systematic view. J Fam Pract 2003; 52: 468-78. (Systematic review of literature found 5 randomized controlled trials of fenugreek in lowering serum cholesterol; cholesterol levels lowered by 15-33%; side effects were mild and largely gastrointestinal). 12791229
Basch E, Ulbricht C, Kuo G, Szapary P, Smith M. Therapeutic applications of fenugreek. Altern Med Rev 2003; 8: 20-7. (Review of the safety and efficacy of fenugreek, most studies showing some effect in lowering blood glucose in open labeled studies but without adequate controls; no reports of clinically significant adverse effects). 12611558
Hasani-Ranjbar S, Nayebi N, Moradi L, Mehri A, Larijani B, Abdollahi M. The efficacy and safety of herbal medicines used in the treatment of hyperlipidemia; a systematic review. Curr Pharm Des 2010;16: 2935-47. (Review of the safety and efficacy of herbal medications used to treat hyperlipidemia including fenugeek, mentions that it has not been associated with significant adverse events). 20858178
Nathan J, Panjwani S, Mohan V, Joshi V, Thakurdesai PA. Efficacy and safety of standardized extract of Trigonella foenum-graecum L seeds as an adjuvant to L-Dopa in the management of patients with Parkinson's disease. Phytother Res 2014; 28: 172-8. (Controlled trial of fenugeek vs placebo in 50 patients with Parkinson disease found no change in serum ALT or AST levels during 6 months of therapy). 23512705
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to various HDS products, none of which were attributed to fenugreek). 25043597
Verma N, Usman K, Patel N, Jain A, Dhakre S, Swaroop A, Bagchi M, et al. A multicenter clinical study to determine the efficacy of a novel fenugreek seed (Trigonella foenum-graecum) extract (Fenfuro™) in patients with type 2 diabetes. Food Nutr Res 2016; 60: 32382. (Among 150 patients with type 2 diabetes treated with fenugreek seed extract or placebo for 90 days, fasting blood glucose levels fell by 30% vs 17% in controls, but HgbA1c and serum aminotransferase levels were unchanged in both groups). 27733237
Steels E, Steele ML, Harold M, Coulson S. Efficacy of a proprietary Trigonella foenum-graecum L. de-husked seed extract in reducing menopausal symptoms in otherwise healthy women: a double-blind, randomized, placebo-controlled study. Phytother Res 2017; 31: 1316-22. (Among 115 healthy, adult women with menopausal symptoms who were treated with a fenugreek seed extract or placebo for 12 weeks, several symptoms improved while "liver function tests remained within normal reference range"). 28707431

## OTHER REFERENCE LINKS

1. Recent References on Fenugreek: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fenugreek+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fenugreek: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fenugreek)